# Brexanolone

## OVERVIEW

### Introduction

Brexanolone is a unique, intravenously administered, neuroactive steroidal antidepressant used in the therapy of moderate-to-severe postpartum depression. In prelicensure clinical trials, brexanolone therapy was not associated with an increased rate of serum aminotransferase elevations, and it has not been linked to instances of clinically apparent acute liver injury.

### Background

Brexanolone (brex an' oh lone) is allopregnanolone an active metabolite of progesterone which is found in high concentrations during pregnancy and falls precipitously at the time of delivery, shortly before the usual time of onset of postpartum depression. When given intravenously in doses that achieve plasma levels typical of pregnancy, brexanolone was found to be associated with marked improvement in depression symptoms, an effect that was sustained when the infusion was stopped. In vitro assays have shown that brexanolone also modulates synaptic and extra-synaptic GABA receptors, another possible mechanism of antidepressant activity. In two randomized controlled trials, a 60 hour intravenous infusion of brexanolone was found to be more effective than placebo in improving depression symptom scales and, in some instances, reversed the functional impairment that often accompanies severe postpartum depression. Brexanolone was approved in the United States in 2019 for use in treatment of moderate or severe postpartum depression. Brexanolone is available in solution in single use vials of 100 mg in 20 mL (5 mg/mL) under the brand name Zulresso. The recommended regimen starts with a dose of 30 mcg/kg/hour, which is gradually increased to a maintenance dose of 90 mcg/kg/hour which is decreased back 30 mcg/kg/hour before stopping, the total duration being 60 hours. Common, nonserious side effects include infusion site discomfort, sedation, headache, dizziness, dry mouth and flushing. Rare, potentially severe adverse events include loss of consciousness and suicidal thoughts or behaviors. The treatment requires continuous monitoring and is typically given in hospital which is often problematic for a new mother.

### Hepatotoxicity

In premarketing studies, liver test abnormalities were uncommon in patients receiving brexanolone (<1%) and no more frequent than in placebo recipients. No instances of acute, clinically apparent liver injury attributed to brexanolone have been reported. However, general clinical experience with brexanolone has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which brexanolone might cause liver injury is not known. Brexanolone is metabolized largely via non-cytochrome P450 pathways, predominantly by keto-reduction, glucuronidation and sulfation. It has few significant drug-drug interactions. Concurrent use of other antidepressants may lead to excess sedation.

Drug Class: Antidepressant Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brexanolone – Zulresso®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brexanolone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Brexanolone | 516-54-1 | C21-H34-O2 | Image of Brexanolone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999, before the availability of brexanolone).
Larrey D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of antidepressants published in 2007 before the availability of brexanolone).
O’Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of the frequency and clinical features of drug induced liver injury due to antidepressants; several SSRIs are discussed [sertraline, paroxetine, fluoxetine, citalopram, fluvoxamine], but not brexanolone). 24362450
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases were attributed to antidepressants including 5 to SSRIs [fluoxetine, escitalopram, sertraline], but none to brexanolone). 25754159
Kanes SJ, Colquhoun H, Doherty J, Raines S, Hoffmann E, Rubinow DR, Meltzer-Brody S. Open-label, proof-of-concept study of brexanolone in the treatment of severe postpartum depression. Hum Psychopharmacol 2017; 32. (Among 4 women with severe postpartum depression treated with brexanolone infusions for 60 hours, all had rapid and striking improvements in depression symptom scores [improving by an average of 91%] and “there were no clinically important changes from baseline in…laboratory parameters”). 28370307
Kanes S, Colquhoun H, Gunduz-Bruce H, Raines S, Arnold R, Schacterle A, Doherty J, et al. Brexanolone (SAGE-547 injection) in post-partum depression: a randomised controlled trial. Lancet 2017; 390 (10093): 480-9. (Among 21 women with severe postpartum depression treated with brexanolone or placebo infusions for 60 hours, depression scores improvement and symptomatic remissions were greater with brexanolone and there were no serious adverse events or early discontinuations, overall adverse events being more frequent in the placebo group; no mention of ALT levels or hepatotoxicity). 28619476
Meltzer-Brody S, Colquhoun H, Riesenberg R, Epperson CN, Deligiannidis KM, Rubinow DR, Li H, et al. Brexanolone injection in post-partum depression: two multicentre, double-blind, randomised, placebo-controlled, phase 3 trials. Lancet 2018; 392 (10152): 1058-70. (Among 246 women with moderate-to-severe postpartum depression treated with 60 hour infusions of brexanolone or placebo in two randomized controlled trials, depression symptom scores improved more with brexanolone, while adverse event rates were similar in the two groups [50% in both] and ALT elevations occurred rarely [<1% vs 2%]. 30177236
Frieder A, Fersh M, Hainline R, Deligiannidis KM. Pharmacotherapy of postpartum depression: current approaches and novel drug development. CNS Drugs 2019; 33: 265-82. (Review of the clinical features, epidemiology, pathogenesis and pharmacotherapy of postpartum depression including use of neuroactive steroids such as brexanolone; no mention of ALT elevations or hepatotoxicity). 30790145

## OTHER REFERENCE LINKS

1. Recent References on Brexanolone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Brexanolone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Brexanolone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brexanolone)